# Trimethobenzamide

## OVERVIEW

### Introduction

Trimethobenzamide is an orally available, antiemetic agent used in the therapy of nausea and vomiting associated with medications and gastrointestinal, viral and other illnesses. Trimethobenzamide has not been linked convincingly to elevations in serum enzymes during therapy and despite widescale use for almost 50 years, it has rarely been linked to instances of clinically apparent liver injury with jaundice.

### Background

Trimethobenzamide (trye meth” oh ben’ za mide) is a benzamide used to prevent nausea and vomiting. Its mechanism of action is uncertain, but it is believed to act directly on the central chemoreceptor nausea trigger zone of the medulla oblongata of the brain. It has weak antihistaminic activity, but does not appear to act via serotonin or dopamine pathways. Trimethobenzamide was approved for use in the United States in 1974 and is widely used in therapy of nausea, vomiting caused by gastroenteritis, medications and other illnesses. Trimethobenzamide is available as 300 mg capsules in generic forms and under the brand name Tigan. It is also available as a solution for injection (100 mg/mL). Trimethobenzamide used to be available also as suppositories, but this formulation was discontinued due to lack of efficacy. The typical oral dose of trimethobenzamide for in adults is 300 mg three or four times a day as needed, usually for short periods only. Intravenous formulations are used for therapy of postoperative nausea and vomiting. Common side effects include drowsiness, dizziness, headache, fatigue, diarrhea and polyuria. Rare side effects include hypersensitivity reactions, skin rash, disorientation, acute dystonic reactions and extrapyramidal symptoms including muscle spasms of the neck and tongue, opisthotonos, restlessness an akinesia.

### Hepatotoxicity

Serum aminotransferase elevations during trimethobenzamide therapy are uncommon and rates of such elevations have not been reported in large clinical trials. A single case report of hepatitis and jaundice attributed to trimethobenzamide was published in 1967 that predated availability of tests for hepatitis A, B and C and of modern imaging studies. The latency to onset was approximately 2 weeks and the pattern of injury was mixed. There were no immunoallergic or autoimmune features and recovery was prompt once the medication was stopped. Since that report, there has only been a single mention of possible hepatotoxicity due to trimethobenzamide, a somewhat prolonged case of hepatocellular injury with a cholestatic pattern on liver biopsy despite minimal jaundice. Thus, clinically apparent liver injury from trimethobenzamide must be very rare and is generally mild and self-limited in course.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Trimethobenzamide is metabolized in the liver but appears to have few drug-drug interactions. The mechanism by which it might cause liver injury is unknown.

### Outcome and Management

The hepatic injury caused by trimethobenzamide is usually mild and reversible with stopping the medication. Trimethobenzamide has not been linked to cases of acute liver failure, chronic hepatitis or vanishing bile duct syndrome. There is no information about possible cross sensitivity to liver injury with other antiemetics or antihistamines. In view of the many other antiemetics available, rechallenge with trimethobenzamide is not necessary and should be avoided.

Drug Class: Gastrointestinal Agents, Antiemetics

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Trimethobenzamide – Generic, Tigan®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Trimethobenzamide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Trimethobenzamide | 138-56-7 | C21-H28-N2-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 03 September 2020

Zimmerman HJ. Antiemetic and prokinetic compounds. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 721. (Expert review of hepatotoxicity published in 1999 lists trimethobenzamide as having caused a single case of cholestatic liver injury [Borda and Jick: 1987]).
Sharkey KA, MacNaughton. Antinauseants and antiemetics: Gastrointestinal motility and water flux, emesis, and biliary and pancreatic disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 934-8. (Textbook of pharmacology and therapeutics).
Brandman O. (1960). Clinical evaluation of the effectiveness and safety of trimethobenzamide (tigan). Gastroenterology. (Among 50 adults with nausea and vomiting of different causes given a single dose of trimethobenzamide [100 mg orally or intramuscularly], 84% appeared to benefit, and no adverse side effects were observed).
Wolfson B, Torres-Kay M, Foldes FF. (1962). Investigation of the usefulness of trimethobenzamide (Tigan) for the prevention of postoperative nausea and vomiting. Anesth Analg. (Among 870 patients undergoing surgery and anesthesia treated with intramuscular trimethobenzamide vs placebo, "side effects attributable to trimethobenzamide were not observed").
Coppolino CA, Wallace G. (1962). Trimethobenzamide antiemetic in immediate postoperative period. Double-blind study in 2,000 cases. JAMA. (Among 2000 patients scheduled for elective surgery given intramuscular injections of trimethobenzamide or placebo, nausea was less in the trimethobenzamide treated subjects; no mention of side effects).
Moertel CG, Reitemeier RJ, Gage RP. (1963). A controlled clinical evaluation of antiemetic drugs. JAMA. (Among 300 patients with cancer receiving fluorouracil who were randomized to receive one of 6 oral antiemetic regimens, the only "significant" side effect was over sedation, which occurred in 8% given prochlorperazine but 0% on trimethobenzamide).
Nichamin SJ. (1964). Severe allergic reaction to an antiemetic trimethobenzamide hydrochloride (Tigan). Harper Hosp Bull. (4 year old boy developed abdominal pain, arthritis and facial edema a few hours after an intramuscular injection of trimethobenzamide [8% eosinophilia, no liver tests reported], resolving within 3-4 days with epinephrine and diphenhydramine).
Bardfeld PA. (1966). A controlled double-blind study of trimethobenzamide, prochlorperazine, and placebo. JAMA. (Among 126 patients with nausea or vomiting of various causes treated with intramuscular injections of trimethobenzamide, prochlorperazine or placebo, drowsiness occurred in 12% and dizziness in 2% of trimethobenzamide treated patients, but no other adverse events were recorded).
Borda I, Jick H. (1967). Hepatitis following the administration of trimethobenzamide hydrochloride. Arch Intern Med. (50 year old woman with breast cancer receiving irradiation therapy developed jaundice 2 weeks after starting oral trimethobenzamide for prevention of nausea [bilirubin 15.3 mg/dL, ALT 330 U/L, Alk P 14.3 Sigma units], resolving within the following month).
Hurley JD, Eshelman FN. (1980). Trimethobenzamide HCl in the treatment of nausea and vomiting associated with antineoplastic chemotherapy. J Clin Pharmacol. (Among 55 patients receiving cancer chemotherapy given intramuscular injections of trimethobenzamide or placebo four times daily for 48 hours, "no side effects attributable to trimethobenzamide were recorded").
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, no cases were attributed to an antiemetic).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to antiemetic agents).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Among 624,673 adverse event reports in children between 2000 and 2006 in the WHO VigiBase, 1% were hepatic, but no antiemetic was listed among the 41 most commonly implicated agents).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to antiemetics).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; no antiemetic was listed).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to trimethobenzamide).
Siddique AS, Siddique O, Einstein M, Urtasun-Sotil E, Ligato S. (2020). Drug and herbal/dietary supplements-induced liver injury: a tertiary care center experience. World J Hepatol. (Among 600 patients who underwent liver biopsy for unexplained rise in serum enzymes over a 5 year period, drug induced liver injury accounted for 38 days, one of which was attributed to trimethobenzamide [bilirubin 15 mg/dL, ALT 630 U/L, Alk P 135 U/L], with a cholestatic hepatitis on biopsy and a prolonged course).

## OTHER REFERENCE LINKS

1 Recent References on Trimethobenzamide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Trimethobenzamide+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Trimethobenzamide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Trimethobenzamide)